# Beta Adrenergic Blocking Agents

## OVERVIEW

The beta-adrenergic receptor antagonists (beta-blockers) are a family of agents that are widely used to treat hypertension, angina pectoris and cardiac arrhythmias. Beta-blockers are also used for migraine prophylaxis, to treat anxiety, to prevent essential tremor, and to block the side effects of hyperthyroidism. Nonspecific beta-blockers are also recommended for treatment of portal hypertension in patients with cirrhosis. The beta-blockers act by competing with beta-adrenergic agonists (such as epinephrine and norepinephrine) for beta-receptor sites. Beta-blockers are often categorized as “selective” or “non-selective” based upon whether they block both beta-1 receptors that are predominantly present in cardiac muscle and beta-2 receptors found in bronchial and smooth muscles. Beta-1 selective blockers are preferred for therapy of heart disease, whereas the nonselective beta-blockers are preferred as therapy to prevent recurrent variceal hemorrhage in patients with cirrhosis and portal hypertension. Nonselective beta-blockers (common brand name and the year of their approval for use in the United States) include propranolol (Inderal, 1967), nadolol (CorGard, 1979), pindolol (Visken, 1982), labetalol (Normodyne, Trandate, 1984), penbutolol (Levatol, 1987), sotalol (Betapace, 1992), carvedilol (Coreg, 1995), and timolol (Biocarden, 1995). Beta-1 selective blockers include metoprolol (Lopressor, Toprol, 1978), atenolol (Temormin, 1981), acebutolol (Sectral, 1984), betaxolol (Kerlone, 1985), esmolol (Brevibloc, 1986), bisoprolol (Zebeta, 1992) and nebivolol (Bystolic, 2008).

Beta-blockers are some of the most frequently used medications in medicine and are usually well tolerated. Common side effects are those that are caused by the beta-adrenergic blockade and include bradycardia, fatigue, dizziness, depression, memory loss, insomnia, impotence, cold limbs and, less commonly, severe hypotension, heart failure and acute bronchospasm. Beta-blockers have been associated with a minimally increased rate of serum aminotransferase elevations and have rarely been associated with clinically apparent liver injury. Isolated case reports of idiosyncratic hepatotoxicity due to beta-blockers have been published, but there have been few case series. The case reports that have been published provide a general pattern of injury with a typical time to onset of 2 to 24 weeks and a hepatocellular pattern of serum enzyme elevations. Most cases have been mild and self-limiting, but fatal cases have been reported. Switching from one beta-blocker to another has not always resulted in recurrence of liver injury, although there have been only rare reports of such cross challenges. Most information on hepatotoxicity is available on the commonly used beta-blockers which include (and the number of prescriptions filled in 2007 for each): atenolol (42 million), metoprolol (27 million), propranolol (6.1 million), bisoprolol (4.3 million), carvedilol (2.9 million), labetalol (2.6 million), and nadolol (1.8 million). Labetalol and acebutolol have been associated with the most numbers of published cases (likelihood scores "C"), which is particularly striking in view of their relative frequency of use. Rare cases have been linked to atenolol, carvedilol and metoprolol therapy (likelihood scores "D").

The different beta-blockers are discussed separately with individual clinical cases, but references are combined and given at the end of this introductory section.

The following links are to individual drug records.

- Acebutolol
- Atenolol
- Betaxolol
- Bisoprolol
- Carvedilol
- Esmolol
- Labetalol
- Metoprolol
- Nadolol
- Nebivolol
- Penbutolol
- Pindolol
- Propranolol
- Sotalol
- Timolol

## ANNOTATED BIBLIOGRAPHY

References updated: 03 June 2018

Zimmerman HJ. Adrenergic blocking agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 658. (Expert review of hepatotoxicity of beta-adrenergic blocking agents published in 1999; mentions that clinically apparent liver injury has been associated with labetalol, dilevalol, acebutolol, atenolol, metoprolol, pindolol and rarely propranolol).
De Marzio DH, Navarro VJ. Antihypertensives. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 522-6. (Review of hepatotoxicity of beta-blockers mentions that there have been few case reports of liver injury due to beta-blockers and that the mechanism is uncertain, the most commonly implicated agent being labetalol).
Eschenhagen T. Treatment of hypertension. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 507-26. (Textbook of pharmacology and therapeutics).
Bolli P, Waal-Manning J, Wood AJ, Simpson FO. Experience with labetalol in hypertension. Br J Clin Pharmacol 1976; 3 (4 Suppl 3): 765-71. (Among 19 patients treated with labetalol in an open label study, one developed AST elevations [initially 27, rising to 120 U/L and falling to 24 U/L with stopping], two patients developed low levels of ANA positivity). 791330
Simpson WT. Nature and incidence of unwanted effects with atenolol. Postgrad Med J 1977; 53: 162-7. (Industry report of side effects among 2600 patients treated with atenolol for 1 month to 4 years; no changes reported in “liver function tests carried out systematically”). 337270
Cody RJ Jr, Calabrese LH, Clough JD, Tarazi RC, Bravo EL. Development of antinuclear antibodies during acebutolol therapy. Clin Pharmacol Ther 1979; 25: 800-5. (Among 11 patients treated with acebutolol for 12 to 24 weeks, 8 [73%] developed ANA titers of 1:10 to 1:160, but none had symptoms of autoimmune conditions and there was a gradual decrease in titers after stopping). 87291
Heel RC, Brogden RN, Speight TM, Avery GS. Atenolol: a review of its pharmacological properties and therapeutic efficacy in angina pectoris and hypertension. Drugs 1979; 17: 425-60. (Thorough review of pharmacokinetics and indications for atenolol). 28096
Simpson FO, Bailey RR, Campbell DG, Dickson DSP, Kiddle GB, Lewis GRJ, Logan R, et al., New Zealand Hypertension Study Group. A multicentre open trial of labetalol in New Zealand. Br J Clin Pharmacol 1979; 8 (Suppl 2): 179S-82S. (Trial of labetalol in 128 hypertensive patients for 6 months or more; side effects occurred in 47% leading to withdrawal in 19%, one patient developed AST rise to 69 U/L, GGT 106 U/L, bilirubin 1.2 mg/dL without symptoms, resolving when drug was stopped). 393287
Jackson DA. Nadolol, a once daily treatment for hypertension: multi-centre clinical evaluation. Br J Clin Pract 1980; 34: 211-21. (Among 10,711 patients with hypertension treated in a large simple trial with nadolol for 6 to 20 weeks, 19% had side effects, mostly dizziness and fatigue; no mention of liver injury or jaundice). 6107120
Timolol-induced reduction in mortality and reinfarction in patients surviving acute myocardial infarction. N Engl J Med 1981; 304: 801-7. (Among 1884 patients with acute myocardial infarction treated with timolol or placebo, no liver related adverse reactions were reported; similar proportion of both groups developed ANA positivity). 7010157
Frishman WH. Nadolol: a new beta-adrenoceptor antagonist. N Engl J Med 1981; 305: 678-82. (Review of pharmacology, mechanism of action, clinical efficacy and safety of nadolol; side effects are similar to those with propranolol; no mention of ALT elevations or liver injury). 6115316
Lebrec D, Poynard T, Hillon P, Benhamou JP. Propranolol for prevention of recurrent gastrointestinal bleeding in patients with cirrhosis: a controlled study. N Engl J Med 1981; 305: 1371-4. (Controlled trial of propranolol [20-180 mg twice daily] vs placebo in 74 patients with cirrhosis after variceal hemorrhage showed decreased rate of rebleeding [4% vs 50%] and no worsening of liver disease; no mention of encephalopathy). 7029276
Michael CA. The evaluation of labetalol in the treatment of hypertension complicating pregnancy. Br J Clin Pharm 1982; 13(Suppl 1): 127S-31S. (Trial of labetalol in 85 women with severe hypertension during pregnancy, no liver test abnormalities, control of blood pressure in >90%). 7093096
Prodanov A, Propvikolov S, Talakov A, Slavinska V. [Liver disorders in Inderal treatment]. Vutr Boles 1982; 11: 110-5. Bulgarian. (2 cases of suspected propranolol hepatotoxicity; patient with arrhythmia treated with cardioversion and propranolol intravenously died of asystole the same day; patient given propranolol intravenously for arrhythmia due to endocarditis after tooth extraction died two days later; liver injury in both cases was probably due to ischemic rather than drug induced liver injury). 4680015
Michelson EL, Frishman WH, Lewis JE, Edwards WT, Flanigan WJ, Bloomfield SS, Johnson BF, et al. Multicenter clinical evaluation of long-term efficacy and safety of labetalol in treatment of hypertension. Am J Med 1983; 75: 68-80. (Open label trail of labetalol given long term in 337 patients; side effects included ALT elevations >2 times ULN in 8%, but many became normal despite continuing therapy and no patient developed symptoms or jaundice). 6356901
Tarver D, Walt RP, Dunk AA, Jenkins WJ, Sherlock S. Precipitation of hepatic encephalopathy by propranolol in cirrhosis. Br Med J(Clin Res Ed) 1983; 287: 585. (69 year old woman with cryptogenic cirrhosis developed worsening hepatic encephalopathy after starting propranolol [40 mg twice daily], and effect was reproduced twice with short reexposures to propranolol). 6411235
McNeil JJ, Louis WJ. Clinical pharmacokinetics of labetalol. Clin Pharmacokinet 1984; 9: 157-67. (Pharmacokinetics of labetalol, the first agent with both alpha and beta-adrenergic receptor blocking activity; it has variable bioavailability and is metabolized by the liver). 6370541
Bigot MC, Trenque T, Moulin M, Beguin J, Loyau G. [Acebutolol and a lupus syndrome. Apropos of a case]. Therapie 1984; 39: 571-5. French. (56 year old woman developed polyarthralgias, ANA of 1:500 and hemolytic anemia 2 years after starting acebutolol, resolving with stopping, ANA falling to 1:50; liver tests normal). 6334376
Hourdebaigt-Larrusse P, Ziza JM, Grivaux M. [A new case of lupus induced by acebutolol]. Ann Cardiol Angeiol(Paris) 1985; 34: 421-3. French. (68 year old man developed polyarthritis and high levels of ANA [1:2560] after 5 years of therapy with acebutolol, improving with discontinuation; liver tests were normal). 3875307
Kunze KD, Porst H, Lohman J, Tschöpel L. [Liver lesions induced by dihydralazine and propranolol]. Zentralbl Allg Pathol 1985; 130: 19-29. German. (Among 16 cases of drug induced liver injury due to dihydralazine and/or propranolol, 2 were treated with propranolol alone, patients were both men, ages 49 and 61 [bilirubin 1.0 and 4.3 mg/dL], no other details provided). 3984541
Kunze KD, Porst H, Tschöpel L. [Morphology and pathogenesis of liver injury produced by dihydralazine, propranolol and ketophenylbutazone]. Zentralbl Allg Pathol 1985; 130: 509-18. (Results of lymphocyte stimulation tests in 28 cases of drug induced liver injury; positive results in 18 cases of dihydralazine and 2 with suspected propranolol hepatotoxicity, both of which were also characterized by bridging necrosis and cholangitis on liver biopsy). 3841742
Wahl J, Singh BN, Thoden WR. Comparative hypotensive effects of acebutolol and hydrochlorothiazide in patients with mild to moderate essential hypertension: a double-blind multicenter evaluation. Am Heart J 1986; 111: 353-62. (Controlled trial of acebutolol vs hydrochlorothiazide [HCT] in 360 patients with hypertension; ANA reactivity arose in 8% on acebutolol vs 2% on HCT, but only one patient developed symptoms which spontaneously resolved despite continuing therapy; no mention of ALT abnormalities). 3511650
Wiesner RH. Does propranolol precipitate hepatic encephalopathy? J Clin Gastroenterol 1986; 8: 74-6. (52 year old woman with primary biliary cirrhosis and varices developed hepatic coma 8 weeks after starting propranolol [20 mg twice daily], resolving completely with stopping propranolol; no rechallenge). 3486211
Roschlau G, Baumgarten R, Binus R. [Nosocomial hepatitis due to propranolol: a report of 3 cases]. Z Klin Med 1987; 42: 1985-8. Not in PubMed (Three cases of liver injury attributed to propranolol, two presenting with fever and one with jaundice, after weeks to months, but largely mild and self-limited; 54 year old woman with fever arising 6 months after starting propranolol [bilirubin 0.5 mg/dL, ALT 212 U/L, Alk P 144 U/L], biopsy showing spotty necrosis, resolving rapidly upon stopping).
Larrey D, Henrion J, Heller F, Babany G, Degott C, Pessayre D, Benhamou JP. Metoprolol-induced hepatitis: rechallenge and drug oxidation phenotyping. Ann Intern Med 1988; 108: 67-8. (56 year old woman developed fatigue 2 weeks after starting metoprolol [bilirubin 0.7 mg/dL, ALT 1140 U/L, Alk P 168 U/L], symptoms and abnormal liver tests resolving within 3 weeks of stopping; rise of ALT from 33 to 66 after 5 days of rechallenge; patient was not a poor metabolizer of metoprolol: Case 1, metoprolol). 3337519
Lennard MS. Metoprolol-induced hepatitis: is the rate of oxidation related to drug-induced hepatotoxicity? Hepatology 1989; 9: 163-4. (Commentary on Larrey [1988] discusses role of poor debrisoquine metabolizing phenotype in drug induced liver injury). 2908864
Douglas DD, Yang RD, Jensen P, Thiele DL. Fatal labetalol-induced hepatic injury. Am J Med 1989; 87: 235-6. (63 year old woman developed jaundice 10 weeks after starting labetalol [bilirubin 3.7 mg/dL, ALT 1,824 U/L, Alk P 205 U/L], resolving within 4 weeks of stopping, but with severe recurrence 2 months after restarting [bilirubin 3.1 rising to 16.8 mg/dL, ALT 535 U/L, Alk P 172 U/L], with progressive hepatic failure and death 6 weeks later). 2757062
Tanner LA, Bosco LA, Zimmerman HJ. Hepatic toxicity after acebutolol therapy. Ann Intern Med 1989; 111: 533-4. (Six cases of possible acebutolol induced liver injury reported to the FDA, 3 men and 3 women, ages 30-66 years, onset after 10 to 31 days, ALT >6 times ULN in all 6, Alk P 220 to 885 U/L, mild jaundice in 2 [bilirubin 2.2 and 4.5 mg/dL], positive rechallenge in 2, all recovered rapidly upon stopping drug). 2774374
Thiele DL. Labetalol hepatotoxicity. Am J Med 1989; 87: 361. (Letter describing 8 reports of labetalol hepatotoxicity made to the FDA that resemble the case described by Douglas [1989]). 2773977
Schwartz MS, Frank MS, Yanoff A, Morecki R. Atenolol-associated cholestasis. Am J Gastroenterol 1989; 184: 1084-6. (73 year old man developed pruritus and abdominal discomfort 9 months after starting atenolol [bilirubin 2.9 mg/dL, ALT 320 U/L, Alk P 100 U/L] which persisted for 6 months until atenolol was stopped, values then becoming normal within 4 weeks). 2773903
Bonkovsky HL, Bonkovsky ML, Anderson PB, Rothstein RI, Erkkinen JF. Atenolol for prevention of rebleeding from esophageal varices in hepatic cirrhosis: results of a controlled, randomized pilot study. Am J Gastroenterol 1989; 84: 681-3. (Small trial of atenolol vs placebo in 20 patients with recent variceal hemorrhage found no difference in rebleeding or survival, suggesting that beta-1 specific agents are ineffective for hemorrhage prevention). 2658555
Clark JA, Zimmerman HJ, Tanner LA. Labetalol hepatotoxicity. Ann Intern Med 1990; 113: 210-3. (Summary of 11 cases of labetalol hepatotoxicity reported to the FDA between 1985 and 1989, 2 men and 9 women, ages 38 to 70 years, with onset after 21-189 days [median 60 days], rash and eosinophilia in one case, [bilirubin 1.2-18.9 mg/dL, ALT 309-4550 U/L, Alk P 102-294 U/L], 3 fatalities). 2375555
Schlanz KD, Thomas RL. Penbutolol: a new beta-adrenergic blocking agent. DICP 1990; 24: 403-8. (Review of pharmacology, clinical efficacy and safety of penbutolol; mild changes in ALT and Alk P have been reported in a few patients, no mention of clinically apparent liver injury). 2183495
Frishman WH, Covey S. Penbutolol and carteolol: two new beta-adrenergic blockers with partial agonism. J Clin Pharmacol 1990; 30: 412-21. (Review of pharmacology, mechanism of action, clinical efficacy and safety of penbutolol and carteolol; no increase in rates of abnormal biochemical tests with penbutolol therapy). 2189902
Michelson EL, Harvengt C. Letters. Labetalol hepatotoxicity. Ann Intern Med 1991; 114: 341. (Two letters mentioning the frequency of ALT elevations in patients who received labetalol in clinical trials [8%] and the hepatotoxicity of dilevalol, a stereoisomer of labetalol). 2018583
Schentke KU, Porst H, Tschöpel L. [Drug-induced liver damage from the clinical viewpoint]. Gastroenterol J 1990; 50: 12-5. German. (Review of drug induced liver injury mentions that propranolol may produce similar hepatotoxicity as dihydralazine; as reported by Kunze [1985]). 2202319
Stumpf JL. Fatal hepatotoxicity induced by hydralazine or labetalol. Pharmacotherapy 1991; 11: 415-8. (73 year old man developed jaundice 2 months after adding labetalol to chronic hydralazine therapy for hypertension [bilirubin 26 mg/dL, ALT 4590 U/L, Alk P 346 U/L], progressing to hepatic failure and death 11 days later). 1745625
Chon EM, Middleton RK. Labetalol hepatotoxicity. Ann Pharmacother 1992; 26: 344-5. (Review of published cases of labetalol hepatotoxicity). 1554954
Maria VA, Victorino RM. Hypersensitivity immune reaction as a mechanism for dilevalol-associated hepatitis. Ann Pharmacother 1992; 26: 924-6. (58 year old woman developed elevations in ALT [10 times ULN] and GGT [5 times ULN] 2 weeks after starting dilevalol for hypertension; few details given; positive lymphocyte stimulation test reported). 1504402
Stronkhorst A, Bosma A, van Leeuwen DJ. A case of labetalol-induced hepatitis. Neth J Med 1992; 40: 200-2. (40 year old woman developed jaundice 16 weeks after starting labetalol [bilirubin 8.9 mg/dL, ALT 916 U/L, Alk P 117 U/L], resolving within 6 weeks of stopping). 1603212
Ruilope LM. Comparison of a new vasodilating beta-blocker, carvedilol, with atenolol in the treatment of mild to moderate essential hypertension. Am J Hypertens 1994; 7: 129-36. (Controlled trial of carvedilol [n=161] vs atenolol [n=164] showed comparability in control of hypetension, adverse events in 21%, no overall change in ALT, AST or Alk P levels, one patient with mild ALT elevations had cholangitis). 7910028
Mamianetti A, Muñoz A, Ronchetti RD, Maccione E, Poggi U, Mugnolo R, Gallo O. [Acquired sideroblastic anemia and cholestasis in a hyperthyroid patient treated with methimazole and atenolol]. Medicina (B Aires) 1995; 55: 693-6. Spanish. (62 year old man developed jaundice 10 days after starting methimazole and atenolol for hyperthyroidism [bilirubin 16 rising to 39 mg/dL, ALT 80 U/L, Alk P 670 U/L], with prolonged jaundice and pruritus, requiring ~12 months to resolve; cholestatic hepatitis most likely due to methimazole). 8731582
Yusuf SW, Mishra RM. Hepatic dysfunction associated with atenolol. Lancet 1995; 346: 192. (78 year old man developed mixed pattern of enzyme elevations [ALT 961 U/L, Alk P 531 U/L] and jaundice [bilirubin 2.4 mg/dL] after a “couple of days” of atenolol therapy, mostly resolved in 1 month after stopping). 7603264
Epeirier JM, Pageaux GP, Coste V, Perrigault PF, Banc P, Larrey D, Michel H. Fulminant hepatitis after carbimazole and propranolol administration. Eur J Gastroenterol Hepatol 1996; 8: 287-8. (57 year old woman developed acute liver failure 6 weeks after starting carbimazole and propranolol for hyperthyroidism [bilirubin 14.6 mg/dL, ALT 1000 U/L, GGT 321 U/L]). 8724032
Anderson JL, Prystowsky EN. Sotalol: An important new antiarrhythmic. Am Heart J 1999; 137: 388-409. (Review of the pharmacology, mechanism of action, efficacy and safety of sotalol in treating cardiac arrhythmias; no discussion of ALT levels or hepatotoxicity). 10047618
Hagmeyer KO, Stein J. Hepatotoxicity associated with carvedilol. Ann Pharmacother 2001; 35: 1364-6. (40 year old man developed pruritus and jaundice 6 months after starting carvedilol [bilirubin not given, ALT 312 U/L, Alk P 202 U/L], resolving within 3 weeks of stopping and recurrent pruritis 10 days after restarting). 11724083
Kootte AM, Janssens AR, Ouwehand DK, van Leeuwen AM. [Chronic hepatitis ascribed to the use of sotalol]. Ned Tijdschr Geneeskd 2001; 145: 2340-3. Dutch. (68 year old woman developed fatigue 3 months after starting sotalol for atrial fibrillation [bilirubin 2.5 rising to 25 mg/dL, ALT 608 U/L, Alk P 170 U/L], with improvement within 5 months of stopping; biopsy suggested chronic hepatitis). 11766306
Marinella MA. Labetalol-induced hepatitis in a patient with chronic hepatitis B infection. J Clin Hypertens (Greenwich) 2002; 4: 120-1. (50 year old man with HBsAg [without HBeAg] was found to have liver test abnormalities, 2 weeks after starting labetalol [bilirubin 1.1 rising to 2.2 mg/dL, ALT 115 to 620 U/L, Alk P 88 to 118 U/L], falling to near normal by 2 weeks after stopping labetalol; no HBV DNA levels provided). 11927791
Poole-Wilson PA, Swedberg K, Cleland JG, Di Lenarda A, Hanrath P, Komajda M, Lubsen J, et al. Comparison of carvedilol and metoprolol on clinical outcomes in patients with chronic heart failure in the Carvedilol Or Metoprolol European Trial (COMET): randomised controlled trial. Lancet 2003; 362: 7-13. (Controlled trial of carvedilol vs metoprolol in 1511 patients with heart failure showed reduction in all cause mortality with carvedilol; rates of adverse events were similar; no mention of ALT elevations or liver injury). 12853193
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, 2 cases were attributed to labetalol). 15390328
Groszmann RJ, Garcia-Tsao G, Bosch J, Grace ND, Burroughs AK, Planas R, Escorsell A, et al.; Portal Hypertension Collaborative Group. Beta-blockers to prevent gastroesophageal varices in patients with cirrhosis. N Engl J Med 2005; 353: 2254-61. (Controlled trial of beta-blockade in patients with cirrhosis without varices found no difference in rate of development of varices with timolol therapy; no hepatic complications linked to timolol therapy). 16306522
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-1101. (Survey of all cases of DILI with fatal outcome from Swedish Adverse Drug Reporting system from 1966-2002: among 103 cases, 1 was attributed to atenolol, but no other beta-blocker was mentioned). 16165719
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, García-Ruiz E, García-Muñoz B, et al.; Spanish Group for the Study of Drug-Induced Liver Disease. Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish registry over a 10-year period. Gastroenterology 2005; 129: 512-21. (Reports of drug induced liver injury to a Spanish network found 570 cases; ACE inhibitors accounted for 8 and angiotensin II receptor blockers for 6 cases, but beta-blockers were not mentioned). 16083708
Björnsson E, Olsson R. Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis 2006; 38: 33-8. (Survey of drug induced liver fatalities reported to WHO database between 1968-2003 revealed 4690 reports – 89% from the US; no beta-blockers were listed in the 20 most commonly implicated agents). 16054882
Cleophas TJ, Agrawal R, Lichtenthal A, Mäkel W, Fici F. Nationwide efficacy-safety study of nebivolol in mildly hypertensive patients. Am J Ther 2006; 13: 192-7. (Evaluation of 6356 hypertensive patients taking nebivolol for at least 3 months in Germany found only mild and uncommon side effects; no serious adverse events and no mention of hepatotoxicity or ALT elevations). 16772759
Ginzburg R, Singleton R, Barr WB. Probable labetalol-induced hepatotoxicity. J Pharmacy Pract 2007; 20: 283-7. Not in PubMed (34 year old woman with eclampsia treated with early delivery and labetolol developed symptoms 4 weeks postpartum [bilirubin 0.5 mg/dL, ALT 833 rising to 1119 U/L, Alk P 269 U/L], with rapid improvement on stopping labetolol).
Weiss RJ, Weber MA, Carr AA, Sullivan WA. A randomized, double-blind, placebo-controlled parallel-group study to assess the efficacy and safety of nebivolol, a novel beta-blocker, in patients with mild to moderate hypertension. J Clin Hypertens (Greenwich) 2007; 9: 667-76. (Controlled trial of 6 doses of nebivolol [1.25-40 mg daily] vs placebo in 909 hypertensive patients; side effects were self-limited, mild and not more frequent than with placebo; laboratory monitoring done, but no mention of change in ALT levels). 17786067
Long R, Wofford M, Harkins K, Minor D. Hepatocellular necrosis associated with labetalol. J Clin Hypertens (Greenwich) 2007; 9: 287-90. (51 year old woman developed jaundice 12 weeks after starting labetalol [bilirubin 7.0 mg/dL, ALT 1102 U/L], worsening despite stopping hydrochlorothiazide [bilirubin 24 mg/dL, ALT 4026 U/L, INR 2.0], progressing to liver failure and need for transplantation). 17396073
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther 2007; 25:1401-9. (Population based survey of 126 cases of acute liver injury [24 with acute liver failure] due to drugs between 1993-1999 in Spain calculated relative risk of injury compared to the general population; atenolol was implicated in 8 cases for a relative risk of 7.2 significantly above expected rate, other beta-blockers were not mentioned). 17539979
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, no beta-blocker was implicated as a single agent). 18955056
Grassin Delyle S, Duverneuil-Mayer C, Abe E, Mathieu B, Lorin De La Grandmaison G, Charlier P, Alvarez JC. Fatal intoxication with labetalol (Trandate). Forensic Sci Int 2008; 178: e19-21. (44 year old woman found dead at home had high levels of labetalol and meprobamate in blood; liver showed mild liver micro- and macro-vesicular steatosis; authors hypothesized possible suicidal overdose with labetalol). 18406090
Gray CL, Ndefo UA. Nebivolol: a new antihypertensive agent. Am J Health Syst Pharm 2008; 65: 1125-33. (Review of pharmacology, pharmacokinetics, clinical efficacy and safety of nebivolol; side effects are similar to those of other beta-blockers, most common being fatigue, headache, bradycardia and dizziness; no mention of ALT elevations or hepatotoxicity). 18541682
Cheng JW. Nebivolol: a third-generation beta-blocker for hypertension. Clin Ther 2009; 31: 447-62. (Systematic review of nebivolol, similar efficacy and side effect profile to other beta-blockers; no mention of ALT elevations or hepatotoxicity). 19393838
Dumortier J, Guillaud O, Gouraud A, Pittau G, Vial T, Boillot O, Scoazec JY. Atenolol hepatotoxicity: report of a complicated case. Ann Pharmacother 2009; 43: 1719-23. (57 year old woman with cryptogenic cirrhosis on long term atenolol therapy underwent liver transplantation and 1 month later was restarted on atenolol and developed hepatitis one month later [bilirubin 2.3 mg/dL, ALT 789 U/L, Alk P 278 U/L], biopsy showing centrolobular necrosis, not responding to pulses of corticosteroids, but resolving within 12 weeks once atenolol was stopped). 19776295
Drugs for hypertension. Treat Guidel Med Lett 2009; 7: 1-10. (Brief overview of currently available drugs for hypertension with guidelines on their use and information on prices and toxicities; “A beta-blocker may be a good choice for treatment of hypertension in patients with another indication for a beta-blocker, such as migraine, angina pectoris, myocardial infarction or heart failure”). 19107095
Greathouse M. Nebivolol efficacy and safety in patients with stage I-II hypertension. Clin Cardiol 2010; 33: E20-7. (Controlled trial in 811 patients with hypertension; side effects were similar in rate to those treated with placebo; no mention of ALT elevations or clinically apparent liver injury). 20162736
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (World wide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, no beta blocker was included among the 41 most frequently implicated agents). 21039766
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed primarily to a beta blocker, although 5 patients were taking a beta blocker [2 on albuterol and 1 each on atenolol, propranol or metoprolol] in addition to the implicated agent). 20949552
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. (Among 313 cases of drug induced liver injury seen between 1997 and 2008 at a large hospital in Bangalore, India, none were attributed to a beta blocker). 20648003
Vicuña-Arregui M, Ruiz-Clavijo-García D, Zozaya-Urmeneta JM, Bolado-Concejo F, Nantes-Castillejo O. [Cholestatic síndrome due to labetalol]. Rev Esp Enferm Dig 2010; 102: 287. Spanish. (15 year old boy developed acute hepatitis two months after starting labetalol and ungoing surgical correction of aortic coarctation, involving blood transfusions [bilirubin 12.9 mg/dL, ALT 894 U/L, Alk P 314 U/L], resolving within 2 months of stopping). 20486755
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to beta-blockers or other antihypertensive medications). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, but none were attributed to a beta-blocker). 24552865
Castiella A, Iglesias U, Zapata E, Zubiaurre L, Iribarren A. [Toxic hepatocellular hepatitis due to labetalol]. Gastroenterol Hepatol 2015; 38: 326-7. (41 year old woman developed asymptomatic elevations in liver tests 12 weeks after starting labetalol for pre-eclampsia [billirubin 0.7 mg/dL, ALT 1133 U/L, Alk P 110 U/L], which fell into the normal range within 2 weeks of stoppin). 25073680
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 39 [4%] were attributed to antihypertensive agents, but only 4 to beta-blockers including 1 each to atenolol, carvedilol, labetalol and metoprolol). 25754159
Firoz T, Webber D, Rowe H. Drug-induced fulminant hepatic failure in pregnancy. Obstet Med 2015; 8: 190-2. (39 year old pregnant woman developed jaundice 8 weeks after starting labetolol and methyldopa [bilirubin 17.8 mg/dL, ALT 1406 U/L, Alk P 159 U/L, ANA 1:320, INR 3.1] with severe course, but ultimate recovery after stopping both agents). 27512479
Hansen T, Fynne L. [Jaundice and liver injury with cholestatic pattern after treatment with metoprolol succinate]. Ugeskr Laeger 2017; 179 (51). pii: V09170698. (80 year old woman developed jaundice two months after starting metoprolol [bilirubin 22.1 mg/dL, ALT 109 U/L, Alk P 378 U/L, INR 1.0], with recovery within 2-3 months of stopping). 29260695
Philips C, Paramaguru R, Mahadevan P, Ravindranath J, Augustine P. Metoprolol-induced severe liver injury and successful management with therapeutic plasma exchange. Cureus 2017; 9: e1209. (56 year old woman developed jaundice 12-14 weeks after starting metoprolol [bilirubin 22.3 mg/dL, ALT 1568 U/L, Alk P 176 U/L, INR 2.6], with acute liver failure but ultimate recovery after stopping and therapy with plasma exchange). 28589058